# Crizotinib

## OVERVIEW

### Introduction

Crizotinib is a selective tyrosine kinase receptor inhibitor used in the therapy of selected cases of advanced non-small cell lung cancer. Crizotinib is associated with transient elevations in serum aminotransferase levels during treatment and rare instances of clinically apparent acute liver injury that can be severe and even fatal.

### Background

Crizotinib (kriz oh’ ti nib) is an orally available, small molecule inhibitor of the tyrosine kinase receptor of mutated anaplastic lymphoma kinase (ALK), which is the result of a chromosomal translocation found in about 5% of lung cancers. Patients with non-small cell lung cancer with the ALK mutation often respond to crizotinib therapy with shrinkage of the tumor and apparent improvement in survival. Crizotinib received accelerated approval for use in the United States in 2011 for the treatment of advanced non-small cell lung cancer with the ALK translocation (a test for this genetic rearrangement was also approved). Crizotinib is available in capsules of 200 and 250 mg under the brand name Xalkori. The recommended dose is 250 mg by mouth twice daily, with dose modification based upon tolerance. Side effects are common and include diarrhea, nausea, vomiting, anorexia, fatigue, constipation, visual disturbances and edema. Uncommon, but potentially serious side effects include interstitial lung disease, QTc interval prolongation and bradycardia.

### Hepatotoxicity

In large early clinical trials, elevations in serum aminotransferase levels occurred in up to 57% of patients treated with standard doses of crizotinib, were greater than 5 times ULN in 6% of patients, and led to early discontinuation of therapy in 2% to 4% of patients. Serum aminotransferase elevations typically arose after 4 to 12 weeks of treatment, but usually without jaundice or alkaline phosphatase elevations. Restarting crizotinib after resolution of the aminotransferase abnormalities can be done starting with a reduced dose. Most cases of liver injury due to crizotinib have been minimally or not symptomatic, and the injury resolved within 1 to 2 months of stopping the drug (Case 1). However, cases with jaundice and symptoms during crizotinib therapy have been reported which were fatal in 0.1% of treated patients (Case 2). The severe cases of liver injury due to crizotinib typically arose within 2 to 6 weeks of starting therapy and presented with marked elevations in serum aminotransferase levels followed by jaundice, progressive hepatic dysfunction, coagulopathy, encephalopathy and death. For these reasons, routine periodic monitoring of liver tests at 2 to 4 week intervals during therapy is recommended.

Likelihood score: C (probable cause of clinically apparent acute liver injury).

### Mechanism of Injury

The cause of the liver injury due to crizotinib is unknown. Crizotinib is metabolized in the liver largely via CYP 3A4, and liver injury may be due to accumulation of a toxic or immunogenic intermediate. Crizotinib is susceptible to drug-drug interactions with medications that inhibit or induce CYP 3A4.

### Outcome and Management

Routine monitoring of liver tests are recommended for patients starting crizotinib, including serum ALT, AST and bilirubin every 2 weeks for the first 2 months and monthly thereafter and as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose interruption. If changes persist, are severe, or reoccur on restarting, crizotinib should be discontinued. There have been reports of acute liver failure, but not of chronic hepatitis or vanishing bile duct syndrome due to crizotinib. Patients with liver abnormalities during crizotinib therapy may tolerate other kinase inhibitors active against non-small cell lung cancer such as erlotinib or gefitinib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## CASE REPORTS

### Case 1. Serum aminotransferase elevations during crizotinib therapy.

[Modified from: Ripault MP, Pinzani V, Fayolle V, Pageaux GP, Larrey D. Crizotinib-induced acute hepatitis: first case with relapse after reintroduction with reduced dose. Clin Res Hepatol Gastroenterol 2013; 37: e21-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/23182672)]

A 69 year old woman with metastatic non-small cell lung cancer developed fatigue 2 months after starting crizotinib (500 mg daily). She had no history of liver disease, risk factors for viral hepatitis or alcohol abuse. Her only other medications were low doses of aspirin (75 mg daily). Physical examination was normal. Laboratory tests showed normal serum bilirubin, but ALT 159 U/L (4.8 times ULN), AST 98 U/L (3 times ULN), but normal alkaline phosphatase, GGT and prothrombin time. Her liver tests had been normal before starting crizotinib (Table). Tests for hepatitis A, B, C and E, CMV, Epstein Barr virus and herpes simplex virus were negative and autoantibodies were not present. Imaging of the liver was normal. Crizotinib was stopped and liver tests improved and were near normal one month later when crizotinib was restarted. Two weeks later, serum aminotransferase levels were again elevated and crizotinib was permanently discontinued.

#### Key Points

Medication: | Crizotinib (500 mg daily)
Pattern: | Hepatocellular (R=~5)
Severity: | 1+ (serum enzyme elevations without jaundice)
Latency: | 8 weeks
Recovery: | 6 weeks
Other medications: | Aspirin

#### Laboratory Values

Time After Starting* | Time After Stopping | ALT (x ULN) | Alk P | Bilirubin (mg/dL) | Other
0 | Pre | <1 | Normal | Normal
3 weeks | Pre | 1.2 | Normal | Normal
8 weeks | 0 | 4.8 | Normal | Normal | Crizotinib stopped
10 weeks | 2 weeks | 3.2 | Normal | Normal
13 weeks | 5 weeks | 1.3 | Normal | Normal | Crizotinib restarted
15 [2] weeks | 0 | 5.3 | Normal | Normal | Crizotinib restopped
16 [3] weeks | 1 week | 2.7 | Normal | Normal
17 [4] weeks | 2 weeks | 1.4 | Normal | Normal
22 [9] weeks | 7 weeks | <1 | Normal | Normal
Normal Values | | <1

*Values in brackets represent number of weeks after restarting crizotinib.

#### Comment

Elevations in serum aminotransferase levels occur in up to 57% of patients treated with crizotinib, but they are usually mild and self-limited. Elevations above 5 times the upper limit (approximately 200 U/L) arise in 5% to 17% of patients and even then may not require drug discontinuation. In this patient, the serum aminotransferase elevations were mild-to-moderate in severity (ALT never rose above 200 U/L), but were associated with symptoms of fatigue. The elevations resolved rapidly upon stopping therapy, but then reappeared with restarting even at a lower dose. The patient was never jaundiced, and alkaline phosphatase and GGT levels were normal. The symptoms were not clearly described and may not have been due to the liver injury, as crizotinib can cause fatigue independent of liver injury. In most patients (but not this one), serum ALT elevations resolve spontaneously either with continuation of therapy or with stopping and restarting at a lower dose.

### Case 2. Fatal liver injury during crizotinib therapy.

[Modified from: van Geel RM, Hendrikx JJ, Vahl JE, van Leerdam ME, van den Broek D, Huitema AD, Beijnen JH,et al. Crizotinib-induced fatal fulminant liver failure. Lung Cancer 2016; 93: 17-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26898609)]

A 62 year old woman with metastatic non-small cell lung cancer [NSCLC] developed abnormal ALT levels 17 days after starting crizotinib [250 mg twice daily], but was continued on therapy until one week later when liver test results were found to have worsened (Table). Crizotinib was stopped but she developed diarrhea, fatigue and jaundice one week later and was admitted. She had no history of liver disease, did not drink alcohol and was taking no other potentially hepatoxic medications. Tests for hepatitis A, B, C and E were negative and ultrasound of the abdomen showed no evidence of biliary obstruction or hepatic masses. She was treated for hepatic failure but devleoped coma, multiorgan failure and died 40 days after starting and 16 days after stopping crizotinib.

#### Key Points

Medication: | Crizotinib (250 mg twice daily)
Pattern: | Hepatocellular (estimated R=~100)
Severity: | 5+ (hepatic failure and death)
Latency: | 2 weeks
Recovery: | None
Other medications: | Not listed

#### Laboratory Values

Time After Starting* | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
0 | | 19 | 184 | 1.0 | Crizotinib started
7 days | | 44 | | 0.2
17 days | | 2062 | | 0.3 | Asymptomatic
24 days | 0 | 6194 | | 1.5 | Crizotinib stopped
31 days | 7 days | ~980 | | 16.8 | Symptomatic
33 days | 9 days | ~600 | | ~20.0 | Admitted
35 days | 11 days | ~400 | | ~19.4 | Coma
40 days | 16 days | ~100 | | ~25.9 | Died
Normal Values | | <40 | <130 | <1.2

*Some values estimated from Figure 1.

#### Comment

This patient developed marked serum aminotransferase elevations within 2 to 3 weeks of starting crizotinib, but was asymptomatic and therapy was not stopped until values were found to continue to rise. Despite stopping, she became jaundiced and rapidly developed hepatic failure, coagulopathy, liver coma and died. The abruptness of onset and severe course suggests a direct hepatotoxicity, but is also compatible with idiosyncracy. Routine monitoring was performed, but the results were not obtained until retrospectively from the critical 17 day time point. Listing of other medications, even if not known to be hepatoxic, would be helpful as crizotinib has extensive hepatic metabolism, largely via CYP 3A4 and is susceptible to drug-drug interactions. Use of potent CYP3A inhibitors or inducers should be avoided during crizotinib therapy.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Crizotinib – Xalkori®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Crizotinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Crizotinib | 877399-52-5 | C21-H22-Cl2-F-N5-O | Crizotinib Chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 30 October 2017

Abbreviations used: NSCLC, non-small cell lung cancer; ALK, anaplastic lymphoma kinase.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Gefitinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; crizotinib is listed as causing moderate-to-severe aminotransferase elevations in 4-7% of patients and as having caused fatal hepatotoxicity in some instances).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Kwak EL, Bang YJ, Camidge DR, Shaw AT, Solomon B, Maki RG, Ou SH, et al. Anaplastic lymphoma kinase inhibition in non-small-cell lung cancer. N Engl J Med 2010; 363: 1693-703. (Screening 1500 patients identified 82 with ALK-positive non-small cell lung cancer [NSCLC], 47 of whom responded at least partially to crizotinib; common side effects were nausea, diarrhea, visual blurring, constipation and fatigue; ALT or AST elevations of above 5 times ULN occurred in 5 patients [5%], all except one of whom could restart the drug at a lower dose without recurrence). 20979469
Camidge DR, Bang YJ, Kwak EL, Iafrate AJ, Varella-Garcia M, Fox SB, Riely GJ, et al. Activity and safety of crizotinib in patients with ALK-positive non-small-cell lung cancer: updated results from a phase 1 study. Lancet Oncol 2012; 13: 1011-9. (Among 149 patients with NSCLC with ALK mutations treated with crizotinib, 61% had an objective response and 97% had at least one adverse event, the most common being visual effects [64%], nausea [56%] and diarrhea [50%], with ALT elevations occurring in 10% and being above 5 times ULN in 3%; among 46 deaths, none were considered drug related). 22954507
Girard N. Crizotinib in ALK-positive lung cancer. Lancet Oncol 2012; 13: 962-3. (Editorial in response to Camidge [2012] with no discussion of potential for hepatotoxicity or ALT elevations). 22954506
Crizotinib (Xalkori) for non-small cell lung cancer. Med Lett Drugs Ther 2012; 54 (1383): 11-2. (Concise review of mechanism of action, efficacy, safety and costs of crizotinib shortly after its accelerated approval in the US; mentions rare, but sometimes severe adverse effects of pneumonitis and QTc prolongation, but does not mention hepatotoxicity). 22354221
Ripault MP, Pinzani V, Fayolle V, Pageaux GP, Larrey D. Crizotinib-induced acute hepatitis: first case with relapse after reintroduction with reduced dose. Clin Res Hepatol Gastroenterol 2013; 37: e21-3. (69 year old woman with NSCLC developed fatigue and ALT elevations 8 weeks after starting crizotinib [ALT 159 U/L, bilirubin and Alk P normal], resolving within 6 weeks of stopping and recurring [ALT 175 U/L] with restarting: Case 1). 23182672
Shaw AT, Engelman JA. ALK in lung cancer: past, present, and future. J Clin Oncol 2013; 31: 1105-11. (Review of the history of discovery of ALK mutations and development of crizotinib as therapy of NSCLC patients with this mutation; no discussion of hepatotoxicity or ALT elevations). 23401436
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; crizotinib is listed as causing liver enzyme elevations in up to 57% of patients [above 5 times ULN in 6%] and having been linked to cases of hepatitis and fatal hepatic failure). 23620168
Timm A, Kolesar JM. Crizotinib for the treatment of non-small-cell lung cancer. Am J Health Syst Pharm 2013; 70: 943-7. (Review of role of crizotinib in therapy of NSCLC mentions that ALT elevations above 5 times ULN occur in 6.7% of patients). 23686600
Shaw AT, Kim DW, Nakagawa K, Seto T, Crinó L, Ahn MJ, De Pas T, et al. Crizotinib versus chemotherapy in advanced ALK-positive lung cancer. N Engl J Med 2013; 368: 2385-94. (Among 347 adults with refractory, advanced, ALK-positive lung cancer treated with crizotinib [250 mg twice daily] or conventional chemotherapy [pemetrexed or docetaxel intravenously every 3 weeks], progression free survival was longer with crizotinib [7.7 vs 3 months] and adverse events included ALT or AST elevations in 38% vs 15%, which were above 5 times ULN in 16% vs 2%, and one patient [0.5%] died of liver failure). 23724913
Mossé YP, Lim MS, Voss SD, Wilner K, Ruffner K, Laliberte J, Rolland D, et al. Safety and activity of crizotinib for paediatric patients with refractory solid tumours or anaplastic large-cell lymphoma: a Children's Oncology Group phase 1 consortium study. Lancet Oncol 2013; 14: 472-80. (Among 79 children with various forms of refractory solid tumors or lymphomas treated with one of 6 doses of crizotinib, ALT elevations occurred in 62% of patients with the first cycle and were above 5 times ULN in 4%; no mention of clinically apparent lier injury). 23598171
Sato Y, Fujimoto D, Shibata Y, Seo R, Suginoshita Y, Imai Y, Tomii K. Fulminant hepatitis following crizotinib administration for ALK-positive non-small-cell lung carcinoma. Jpn J Clin Oncol 2014; 44: 872-5. (54 year old woman with advanced, ALK-positive lung cancer developed malaise 29 days after starting crizotinib [bilirubin 2.7 rising to 4.7 mg/dL, ALT 5201 U/L, Alk P 506 U/L, prothrombin index less than 10%], with progressive liver failure and death 6 days after presentation). 24966207
Tsukita Y, Fukuhara T, Kobayashi M, Morita M, Suzuki A, Watanabe K, Noguchi T, et al. Alternate-day treatment with crizotinib for drug-induced esophagitis and liver damage in a patient with EML4-ALK fusion gene-positive lung adenocarcinoma. Intern Med 2015; 54: 3185-8. (44 year old woman with refractory, metastatic ALK-positive lung cancer developed esophagitis and ALT elevation shortly after starting crizotinib, which improved upon stopping and did not recur on restarting at a reduced dose [alternative day, actual dose not given]). 26666609
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases [6%] were attributed to antineoplastic agents, including 9 due to kinase inhibitors such as imatinib and lapatinib, but none were attributed to crizotinib). 25754159
van Geel RM, Hendrikx JJ, Vahl JE, van Leerdam ME, van den Broek D, Huitema AD, Beijnen JH, et al. Crizotinib-induced fatal fulminant liver failure. Lung Cancer 2016; 93: 17-9. (62 year old woman with advanced, ALK-positive NSCLC developed liver test abnormalities [ALT 2062 U/L] followed by jaundice one week later [bilirubin 1.5 rising to 26.3 mg/dl], hepatic failure and death 40 days after starting and 2 weeks after stopping crizotinib: Case 2). 26898609
Zhang Q, Qin N, Wang J, Lv J, Yang X, Li X, Nong J, et al. Crizotinib versus platinum-based double-agent chemotherapy as the first line treatment in advanced anaplastic lymphoma kinase-positive lung adenocarcinoma. Thorac Cancer 2016; 7: 3-8. (Among 19 patients with previously-untreated, advanced, ALK-positive lung cancer treated with crizotinib compared to 12 patients given conventional chemotherapy, overall response rates were higher with crizotinib [83% vs 25%], but side effects were greater including visual disturbances, diarrhea and abnormal "liver function" in 28% vs 8%; no mention of clinically apparent liver injury). 26816533

## OTHER REFERENCE LINKS

1. Recent References on Crizotinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Crizotinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Crizotinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Crizotinib)